# Lerodalcibep

## OVERVIEW

### Introduction

Lerodalcibep is a recombinant fusion protein and potent inhibitor of proprotein convertase subtilisin/kexin type 9 (PCSK9) that is used to reduce low-density lipoprotein (LDL) cholesterol in patients’ hypercholesterolemia and at high risk of atherosclerotic cardiovascular disease. Lerodalcibep has not been associated with serum aminotransferase elevations during therapy or with instances of clinically apparent liver injury with jaundice.

### Background

Lerodalcibep (ler” oh dal’ si bep) is a subcutaneously injected, recombinant fusion protein and PSCK9 inhibitor used to decrease low density lipoprotein (LDL) cholesterol levels in adults at high risk for atherosclerotic cardiovascular disease whose LDL cholesterol has not been adequately controlled with statins or other standard therapies. PCSK9 is a circulating serum protein that binds to the hepatocyte LDL receptor and leads to its internalization and degradation. In the absence of its receptor, LDL cholesterol remains in the circulation and can lead to arterial plaque formation and atherosclerotic cardiovascular, cerebrovascular, and/or peripheral-vascular disease. Lerodalcibep is a fusion protein of recombinant adnexin (the PCSK9 binding domain) and human serum albumin (which is used to prolong the protein’s half-life). In several randomized controlled trials, lerodalcibep when added to optimal statin therapy was shown to lower serum LDL cholesterol by more than 50% compared to addition of placebo. Therapy also improved levels of other atherosclerotic lipoproteins such as apolipoprotein B and lipoprotein(a). Controlled trials of lerodalcibep therapy focusing upon prevention of long-term cardiovascular outcomes are currently ongoing. Lerodalcibep was approved as an LDL-cholesterol lowering agent in the United States in 2026 and is available as a solution in 300 mg vials under the trade name Lerochol. The recommended dose is 300 mg given subcutaneously once monthly. Common side effects include injection site reactions, diarrhea, nausea, nasopharyngitis, and peripheral edema. Side effects are usually transient and mild to moderate in severity. Potentially severe adverse events are rare but may include hypersensitivity reactions, bradycardia, syncope, and embryo-fetal toxicity (based upon studies in laboratory animals).

### Hepatotoxicity

In pre-registration clinical trials in more than 1,800 patients with hypercholesterolemia, rates of liver test abnormalities were similar in those receiving lerodalcibep compared to those on placebo. ALT levels above 3 times the upper limit of normal (ULN) arose in 0.2% vs 0.8% and above 5 times ULN in 0.2% vs 0.2%. One patient receiving lerodalcibep developed an autoimmune-like hepatitis that was judged possibly related to therapy and was treated promptly with corticosteroids. In multiple other studies there were similarly low rates of liver test abnormalities and no instances of clinically apparent liver injury with jaundice attributable to lerodalcibep. The total use of lerodalcibep since its approval has been limited and the assigned likelihood score should be considered preliminary.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which lerodalcibep might cause liver injury is not known. Lerodalcibep is a recombinant fusion protein of adnexin and albumin and is metabolized in the liver and possibly other cells into smaller polypeptides and individual amino acids. There is the possibility that adnexin has other effects on hepatocytes (besides binding to the LDL receptor) or has effects on the immune system that might indirectly cause liver injury.

### Outcome and Management

Lerodalcibep has not been linked to serum aminotransferase elevations during therapy nor to convincing instances of clinically apparent liver injury. It is given long-term and delayed adverse events may not have been identified in the pre-registration trials.

Drug Class: Antilipidemic Agents; PCSK9 inhibitors

Other Drugs in the Subclass: Alirocumab, Evolocumab, Inclisiran

PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Lerodalcibep – Lerochol®

DRUG CLASS

Antilipidemic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Lerodalcibep)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Lerodalcibep | 2250073-78-8 | C_3427 H_5324 N_908 O_1045 S_40 | SID: 505794687

## ANNOTATED BIBLIOGRAPHY

References updated: 29 July 2026

Abbreviations used: ULN, upper limit of normal; sc, subcutaneously.

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Expert review of hepatotoxicity of antibiotics published in 1999, before the availability of PCSK9 inhibitors).
MacDougall C. Protein synthesis inhibitors and miscellaneous antibacterial agents. In, Brunton LL, Hilal-Dandan R, Knollman KC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1049-65 (Textbook of pharmacology and therapeutics, published before the availability of PCSK9 inhibitors). https://www.accessdata.fda.gov/drugsatfda_docs/nda/2026/761427Orig1s000TOC.html (FDA website with product label and FDA integrated review of efficacy and safety of lerodalcibep, based upon data submitted by the sponsor in support of its approval as therapy of hypercholesterolemia, mentions that in the large pre-registration randomized controlled trials that enrolled more than 1800 patients adverse event rates were similar with monthly subcutaneous (sc) injections of lerodalcibep as with sc placebo treatment [overall 75% vs 75%, severe 10% vs 9%, leading to discontinuation 5.4% vs 5.1%] and that there was no evidence for significant liver injury, ALT elevations above 3 times ULN arising in 0.2% vs 0.8% and above 5 times ULN in 0.2% vs 0.5% with no case of aminotransferase elevations and jaundice).
Raal F, Fourie N, Scott R, Blom D, De Vries Basson M, Kayikcioglu M, Caldwell K, et al; LIBerate-HeFH Investigators. Long-term efficacy and safety of lerodalcibep in heterozygous familial hypercholesterolemia: the LIBerate-HeFH trial. Eur Heart J. 2023 Oct 21;44(40):4272-4280. PMID: (Among 478 patients with heterozygous familial hypercholesterolemia treated with lerodalcibep [300 mg] or placebo sc monthly for 6 months, adverse event rates were similar in the two groups while ALT or AST elevations arose in 0.6% vs none, but no patient develop clinically apparent liver injury). 37639462
Klug EQ, Llerena S, Burgess LJ, Fourie N, Scott R, Vest J, Caldwell K, Kallend D, Stein EA; LIBERATE-HR Investigators. Efficacy and safety of lerodalcibep in patients with or at high risk of cardiovascular disease: a randomized clinical trial. JAMA Cardiol. 2024;9:800-807. PMID: (Among 922 patients with hypercholesterolemia and high risk of atherosclerosis on maximally tolerated statins, addition of lerodalcibep [300 mg] vs placebo sc monthly for 52 weeks led to a further 50% decrease in LDL cholesterol with similar rates of adverse events [72% vs 68%] and no episodes of clinically apparent liver injury). 38958989
Raal FJ, Mehta V, Kayikcioglu M, Blom D, Gupta P, Elis A, Turner T, et al. Lerodalcibep and evolocumab for the treatment of homozygous familial hypercholesterolemia with PCSK9 inhibition (LIBerate-HoFH): a phase 3, randomised, open-label, crossover, non-inferiority trial. Lancet Diabetes Endocrinol. 2025;13:178-187. PMID: (In a cross-over comparison of monthly sc injections of lerodalcibep vs evolocumab in 66 patients with homozygous familial hypercholesterolemia, the two agents had similar LDL cholesterol lowering activity at 24 weeks [-5% vs -10%], and serum aminotransferase elevations above 3 times ULN were rare with both [2% vs 2%, 1 case each). 39870096
Zhuang-Yan A, Blair HA. Lerodalcibep: first approval. Drugs. 2026 Apr 7. Epub ahead of print. PMID: (Review of the mechanism of action, history of development, pharmacology, clinical efficacy, and safety of lerodalcibep shortly after its approval for use in the United States, does not mention ALT elevations of hepatotoxicity). 41945308
Lerodalcibep (Lerochol) for hypercholesterolemia. Med Lett Drugs Ther. 2026;68(1754):71-75. PMID: (Concise review of the mechanism of action, clinical efficacy, safety, and costs of lerodalcibep shortly after its approval in the United States as therapy of hypercholesterolemia; mentions common minor adverse events but does not mention serious adverse events, ALT elevations, or hepatotoxicity). 42068312
Drugs for hypercholesterolemia. Med Lett Drugs Ther. 2026;68(1756):89-95. PMID: (Concise review of the mechanism of action, clinical efficacy, safety, and costs of FDA approved drugs for hypercholesterolemia including statins, cholesterol absorption inhibitors, adenosine triphosphate-citrate lyase inhibitors, bile acid sequestrants, and PCSK9 inhibitors, mentions hepatotoxicity of statins, ezetimibe, and bempedoic acid but does not mention ALT elevations or hepatotoxicity of PCSK9 inhibitors including lerodalcibep). 42223920

## OTHER REFERENCE LINKS

1. Recent References on Lerodalcibep: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Lerodalcibep%20+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Lerodalcibep: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Lerodalcibep)